# Clotrimazole

## OVERVIEW

### Introduction

Clotrimazole is an imidazole antifungal agent used primarily in the treatment of skin, oral and vaginal candida infections. Clotrimazole is typically given topically or as oral or vaginal troches and has only modest systemic absorption. Nevertheless, clotrimazole given orally or as troches has been associated with transient and asymptomatic serum aminotransferase elevations during therapy, but it has not been linked to instances of clinically apparent acute liver injury.

### Background

Clotrimazole (kloe trim' a zole) is a synthetic imidazole that has broad spectrum activity against Candida albicans and other yeast species. The azoles are believed to act by disruption of the fungal cell wall membrane. Clotrimazole is typically given topically or as oral or vaginal troches. When given as an oral troche, it should be allowed to dissolve in the mouth and not swallowed. Systemic absorption occurs even with the oral troche, but concentrations adequate as therapy of candida infections are found only in local oral tissue and saliva. Clotrimazole given orally (swallowed) was used in the past to treat various forms of candida infections, but it is not currently approved as tablets or capsules for gastrointestinal absorption. Clotrimazole was approved for use in the United States in 1975 and subsequently became available over-the-counter in topical creams (for superficial fungal infections) and vaginal formulations (for fungal vaginitis). The oral troche (lozenge) remains available only by prescription as large, slowly dissolving tablets (lozenges) containing 10 mg of clotrimazole generically and under commercial names such as Mycelex and Lotrimin. Current indications for the oral lozenges are as treatment or prevention of oropharyngeal candidiasis (oral thrush). The recommended regimen is one troche five times daily for 7 to 14 days. The vaginal troche is used once daily for 3 to 7 days. Side effects are not common but can include headache, nausea and itchiness. Side effects of topical administration include local rash, redness and burning. Serious adverse reactions are very rare.

### Hepatotoxicity

Transient elevations in serum aminotransferase levels occur in up to 15% of patients treated with clotrimazole orally. The elevations are generally mild-to-moderate in degree and resolve spontaneously with or without discontinuation. Despite decades of widespread use, clotrimazole has not been linked to instances of clinically apparent hepatotoxicity.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the serum enzyme elevations during clotrimazole therapy is unknown, but many of the antifungal azoles have been implicated in causing liver injury. Because there is minimal systemic absorption, clotrimazole concentrations may not reach levels that could cause significant liver injury. Clotrimazole is metabolized in the liver via the cytochrome P450 system and can inhibit via CYP 3A4 activity and thus cause significant drug interactions with agents that are CYP 3A4 substrates. Because of its metabolism, the liver injury might be caused by a toxic or immunogenic intermediate.

### Outcome and Management

The serum enzyme elevations attributed to clotrimazole therapy are usually mild and transient and rarely require dose adjustment or discontinuation. Nevertheless, the product labels for clotrimazole mention hepatotoxicity and recommend "periodic assessment of hepatic function", particularly in patients with preexisting liver disease. There is no information about cross sensitivity to hepatic injury between clotrimazole and other azole antifungal agents.

Drug Class: Antifungal Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Clotrimazole – Generic, Lotrimin®, Mycelex® (Troche)

DRUG CLASS

Antifungal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=nystatin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Clotrimazole | 23593-75-1 | C22-H17-Cl-N2 | Image of Clotrimazole Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2019

1. Zimmerman HJ. Antifungal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 609-11. (Expert review of hepatotoxicity of antifungal agents published in 1999; mentions that 5-15% of clotrimazole treated subjects have elevations of aminotransferase, alkaline phosphatase or bilirubin levels, but that there is inadequate information on its potential for hepatotoxicity).
Moseley RH. Antifungal agents. Antibacterial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 470-81. (Review of hepatotoxicity of antifungal agents; clotrimazole is not discussed).
Rogers PD, Krysan DJ. Antifungal agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1087-1104. (Textbook of pharmacology and therapeutics).
Spiekermann PH, Young MD. Clinical evaluation of clotrimazole. A broad-spectrum antifungal agent. Arch Dermatol 1976; 112: 350-2. (Among 1361 patients with various dermatomycoses treated with 1% clotrimazole solutions or creams vs matched placebos, clinical and mycological responses were higher with clotrimazole, and adverse events were rare [2.7%] and no more common than with placebo [3%]). 769697
Rockoff AS. Chronic mucocutaneous candidiasis. Successful treatment with intermittent oral doses of clotrimazole. Arch Dermatol 1979; 115: 322-3. (9 year old child with chronic mucocutaneous candidiasis was successfully managed with intermittent course of oral clotrimazole [500 mg 3 times daily for 2 weeks] and “the only toxicity was transient elevations of liver enzyme levels”). 434848
Yap BS, Bodey GP. Oropharyngeal candidiasis treated with a troche form of clotrimazole. Arch Intern Med 1979 139: 656-7. (Among 56 cancer patients with 60 episodes of oropharyngeal candidiasis treated with clotrimazole [10 or 50 mg troches 5 times daily for an average of 14 days], 96% of both groups were cured and side effects “were minimal” and no abnormal biochemical finding “could be reasonably attributed to treatment”). 375858
Hughes D, Kriedman T. Treatment of vulvovaginal candidiasis with a 500-mg vaginal tablet of clotrimazole. Clin Ther 1984; 6: 662-8. (Among 26 women with vulvovaginal candidiasis enrolled in a randomized control trial, 9 of 10 treated with a single 500 mg tablet of clotrimazole but none of the placebo controls had a clinical and mycological response and no patients reported any adverse reactions). 6383612
Evans EG, Dodman B, Williamson DM, Brown GJ, Bowen RG. Comparison of terbinafine and clotrimazole in treating tinea pedis. BMJ 1993; 307 (6905): 645-7. (Among 211 patients with tinea pedis treated with terbinafine or clotrimazole cream for 4 weeks, clinical and mycological cure rates were higher with terbinafine and adverse events were minimal and limited to local side effects of burning, itching, redness and rash). 8401048
Stein GE, Mummaw N. Placebo-controlled trial of itraconazole for treatment of acute vaginal candidiasis. Antimicrob Agents Chemother 1993; 37: 89-92. (Among 95 women with vaginal candidiasis treated with itraconazole, clotrimazole or placebo, clinical and mycological responses were similar between the two drugs and greater than with placebo, while side effects arose in 17 [35%] on itraconazole, 1 [4%] on clotrimazole and 9 [41%] on placebo; one subject on itraconazole had transient [1 week] ALT elevations). 8381643
O-Prasertsawat P, Bourlert A. Comparative study of fluconazole and clotrimazole for the treatment of vulvovaginal candidiasis. Sex Transm Dis 1995; 22: 228-30. (Among 103 women with vulvovaginal candidiasis treated with a single oral dose of fluconazole or with 3 days of twice daily clotrimazole, clinical and mycological cure rates were similar and adverse event rates were uncommon, the vaginal clotrimazole troches associated with mild-to-moderate vaginal burning in 22% of subjects; no mention of hepatotoxicity). 7482105
Song J, Deresinski S. Hepatotoxicity of antifungal agents. Curr Opin Investig Drugs 2005; 6: 170-7. (Extensive review of hepatotoxicity from antifungals; clotrimazole is not discussed). 15751740
Vazquez JA, Patton LL, Epstein JB, Ramlachan P, Mitha I, Noveljic Z, Fourie J, et al.; SMiLES Study Group. Randomized, comparative, double-blind, double-dummy, multicenter trial of miconazole buccal tablet and clotrimazole troches for the treatment of oropharyngeal candidiasis: study of miconazole Lauriad® efficacy and safety (SMiLES). HIV Clin Trials 2010; 11: 186-96. (Among 577 patients with HIV infection and oropharyngeal candidiasis treated with miconazole [once daily] or clotrimazole [5 times daily] for 14 days, clinical cure rates were similar as were adverse event rates; GGT elevations occurring in 1% vs 3% and there were no hepatic serious adverse events or deaths). 20974574
Wang JL, Chang CH, Young-Xu Y, Chan KA. Systematic review and meta-analysis of the tolerability and hepatotoxicity of antifungals in empirical and definitive therapy for invasive fungal infection. Antimicrob Agents Chemother 2010; 54: 2409-19. (Systematic review of 39 controlled trials of antifungal agents in more than 8000 patients, but clotrimazole is not discussed). 20308378
Antifungal drugs. Treat Guidel Med Lett 2012; 10: 61-8. (Concise summary of therapy of systemic fungal infections with recommendations on agents, dosage and duration of treatment and safety; no discussion of clotrimazole). 22825657
Kao WY, Su CW, Huang YS, Chou YC, Chen YC, Chung WH, Hou MC, et al. Risk of oral anti-fungal agent-induced liver injury in Taiwanese. Br J Clin Pharmacol 2014; 77: 180-9. (Analysis of Taiwan National Health Insurance database from 2002-2008 identified 52 patients with drug induced liver injury among 90,847 users of oral antifungal agents, including 28 [54%] due to ketoconazole, 12 fluconazole, 8 griseofulvin, 3 itraconazole, 2 terbinafine, but clotrimazole was not included in the analysis). 23750489
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 14 were attributed to antifungal agents, including 6 to azoles but none to clotrimazole). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Clotrimazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Clotrimazole)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222010/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Clotrimazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Clotrimazole)